# Trisalicylate

## OVERVIEW

### Introduction

Choline magnesium trisalicylate is a nonacetylated dimer of salicylic acid that is used in the therapy of chronic arthritis and for general management of pain and fever. Trisalicylate has been linked to rare instances of acute, clinically apparent liver injury.

### Background

Trisalicylate (trye" sa lis' i late) is a nonacetylated salicylic acid that has antiinflammatory, analgesic and antipyretic actions similar to aspirin. The antiinflammatory and analgesic effects of trisalicylate are probably mediated by its inhibition prostaglandin synthesis. Choline magnesium trisalicylate is similar in efficacy to aspirin, but is reported to have fewer side effects. Although available for several decades, it is less commonly used than typical nonsteroidal antiinflammatory agents. Trisalicylate is indicated for the treatment of chronic arthritis due to osteoarthritis or rheumatoid arthritis and for minor-to-moderate pain. Trisalicylate is available by prescription only as tablets of 500, 750 and 1000 mg in generic forms and under the brand name of Trilisate. It is also available as an oral solution. The recommended regimen is 750 to 1500 mg twice daily, based upon response and tolerance. Common side effects are intestinal upset, nausea, headache, dizziness, somnolence, tinnitus, rash and hypersensitivity reactions.

### Hepatotoxicity

Prospective studies show that a proportion of patients taking choline magnesium trisalicylate experience at least transient serum aminotransferase elevations. These may resolve even with drug continuation, particularly if the dose is reduced. Marked aminotransferase elevations (>3 fold elevated) can occur with high doses in patterns that resemble aspirin induced hepatotoxicity. At least one instance of clinically apparent liver injury with jaundice has been reported with onset within a week of starting trisalicylate and characterized by a mixed pattern of enzyme elevations and potentially severe course. Fever, rash and eosinophilia did not occur and autoantibodies were not present. Trisalicylate is probably capable of inducing Reye syndrome in a susceptible child or adolescent and, like aspirin, should be avoided in those age groups.

Likelihood score: A[HD]: (well established cause of clinically apparent liver injury when given in high doses).

### Mechanism of Injury

The mechanism of trisalicylate hepatotoxicity is likely hypersensitivity in instances of jaundice associated with standard doses. In addition, trisalicylate in high doses probably has a direct hepatotoxic effect resembling that of aspirin.

### Outcome and Management

A single case report of acute liver failure with ultimate recovery has been published. No instances of chronic liver disease or vanishing bile duct syndrome due to trisalicylate have been published. Patients with hypersensitivity to trisalicylate should probably avoid other nonacetylated salicylates.

Drug Class: Salicylates

Other Drugs in the Class: Aspirin, Diflunisal, Salsalate

## CASE REPORT

### Case 1. Serum enzyme elevations during choline magnesium trisalicylate therapy.(1)

A 21 year old woman had systemic lupus erythematosus, but was on no specific therapy. She developed a persistent cough that was then followed by fever, headache and fatigue. Evaluation found no specific cause and she was started on trisalicylate in a dose of 1500 mg twice daily to treat a suspected worsening of the underlying lupus erythematosus. Within four days, serum enzymes which had been mildly abnormal began to rise (Table). Trisalicylate was stopped and one day later serum ALT levels began to fall, although they were still elevated at the time of discharge and no follow up was available. Testing done on admission suggested that the fever and cough were due to cytomegalovirus infection and not to worsening of lupus erythematosus.

#### Key Points

Medication: | Choline magnesium trisalicylate (3.0 g daily)
Pattern: | Mixed (R=4.5)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 4 days
Recovery: | Rapid, but not documented to be complete
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 79 | 164 | 0.8 | Admission for fever and headache
Pre | | 84 | 290 | 0.4 | IgM anti-CMV positive
Pre | | 15 | 100 | 0.6
| | Trisalicylate started (1.5 g twice daily)
3 days | | 63 | 357 | 0.2
6 days | 0 | 555 | 371 | 0.3 | Trisalicylate stopped
7 days | 1 day | 590 | 376 | 0.3
8 days | 2 days | 383 | 326 | 0.5
9 days | 3 days | 190 | 275 | 0.4
| | Patient discharged; no follow up available
Normal Values | | <41 | <110 | <1.2

#### Comment

A typical pattern of serum enzyme elevation in salicylate hepatotoxicity occurring within days of starting therapy with choline magnesium trisalicylate and improving within a few days of stopping. CMV hepatitis is also a possibility, although the timing in relationship to starting the medication favors drug induced liver injury. Salicylate hepatotoxicity is generally asymptomatic, anicteric and rapidly reversible.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trisalicylate – Generic, Trilisate® (not available in U.S.), Generic

DRUG CLASS

Antiinflammatory Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=ac5d0d81-5c64-4344-850d-34946b3252b1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Choline Magnesium Salicylate | 64425-90-7 | C7-H6-O3.C7-H5-O3. C5-H14-N-O.1/2Mg

## CITED REFERENCE

1 Cersosimo RJ, Matthews SJ. (1987). Hepatotoxicity associated with choline magnesium trisalicylate: case report and review of salicylate-induced hepatotoxicity. Drug Intell Clin Pharm.

## ANNOTATED BIBLIOGRAPHY

References updated: 15 August 2020

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. Chapter 19: The NSAIDS. In Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams & Williams, 1999, pp. 517-41. (Review of hepatotoxicity of salicylates published in 1999, discusses aspirin).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists: pathology and clinical presentation of hepatotoxicity. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. pp. 370-402. (Expert review of liver injury caused by NSAIDs mentions that choline magnesium trisalicylate can cause hypersensitivity reactions and accompanying liver injury).
Burke A, Smyth E, FitzGerald GA. Analgesic-antipyretic and antiinflammatory agents: pharmacotherapy of gout. Chapter 26. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp 671-715. (Textbook of pharmacology and therapeutics).
Blechman WJ, Lechner BL. (1979). Clinical comparative evaluation of choline magnesium trisalicylate and acetylsalicylic acid in rheumatoid arthritis. Rheumatol Rehabil. (Comparison of trisalicylate with aspirin in rheumatoid arthritis; trisalicylate was as effective and had fewer side effects, and no abnormal laboratory results were found on testing after 7 weeks of therapy).
Cersosimo RJ, Matthews SJ. (1987). Hepatotoxicity associated with choline magnesium trisalicylate: case report and review of salicylate-induced hepatotoxicity. Drug Intell Clin Pharm. (21 year old woman with lupus developed rising serum aminotransferase levels when placed on trisalicylate, resolving with discontinuation: no jaundice: Case 1).
Le Gallez P, Bird HA, Wright V. (1990). A comparison of choline magnesium trisalicylate and acetylsalicylic acid in patients with rheumatoid arthritis. Curr Med Res Opin. (Crossover 3 week study in 19 patients with rheumatoid arthritis with ALT monitoring, "as far as one could tell, there was no significant differences in the frequency of side-effects").
Nadkarni MM, Peller CA, Retig J. (1992). Eosinophilic hepatitis after ingestion of choline magnesium trisalicylate. Am J Gastroenterol. (66 year old woman developed jaundice 3 days after stopping 3 day course of trisalicylate for osteoarthritis [bilirubin 7.0 rising to 14.3 mg/dL, ALT 774 U/L, Alk P 542 U/L], with severe course, but ultimate recovery; biopsy showed hepatitis with eosinophils; no rash or fever, ANA negative).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; trisalicylate not mentioned).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were due to choline magnesium trisalicylate or other salicylates).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were due to choline magnesium trisalicylate or other salicylates).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were due to nonsteroid antiinflammatory agents, one to salsalate but none to choline magnesium trisalicylate).

## OTHER REFERENCE LINKS

1 Recent References on Trisalicylate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=trisalicylate+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Trisalicylate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=trisalicylate)